# Dragon’s Blood

## OVERVIEW

### Introduction

Dragon’s blood is a red resin obtained from the sap of several species of plants that is used as a varnish, paint pigment, and dye, but also as a traditional medicine, used topically as an astringent and orally as treatment for diarrhea and digestive diseases. Therapy with dragon’s blood has not been linked to elevations in serum enzymes or to instances of clinically apparent liver injury.

### Background

Dragon’s blood is a red resin obtained from sap of several species of trees (often known as dragon trees) that is used as a varnish, paint pigment, and dye, but also as a traditional herbal medicine applied topically as an astringent for wound healing and taken orally to treat digestive disorders and diarrhea. Dragon’s blood is obtained from the sap of the cut stems of several plant species, based upon the locality. The most common sources are Calamus draco (previously known as Daemonorops draco, native to Indonesia and Malaysia), Croton lechleri (also known as Sangre de Drago, native to South America and the source of the antidiarrhea agent crofelemer), Pterocarpus species (native to the West Indies), and Dracaena cinnabari and draco (native to the Yemen and the Arabian Peninsula). Chemical analyses of dragon’s blood extracts demonstrate hundreds of components including bexarotene, taspine, proanthocyanidins, catechins, aldehydes, flavonoids, tannins, terpenes, and steroids. Which ingredient or ingredients are responsible for the purported medicinal effects of dragon’s blood are unclear and may vary by species and medicinal effects. Dragon’s blood is used topically in liquids, ointments, and creams for wound healing and hemostasis, and for insect bites and herpetic ulcers. Oral formulations have been purported to have antidiarrheal, antiulcer, antirheumatic, analgesic, antiinflammatory, antioxidant, hypoglycemic, cardiotonic, neuroprotective and antineoplastic activities in vitro and in animal models, and extracts of the South American Dragon tree Croton lechleri have been approved for treatment of non-infectious diarrhea in HIV-positive persons (crofelemer). The other purported systemic effects of dragon’s blood, however, have not been substantiated in controlled trials in humans. Dragon’s blood is available over-the-counter in several forms including liquid solutions, capsules and powders for oral use and creams and ointments for topical use. Adverse events are few and nonspecific, the topical forms occasionally causing burning or itch and the oral forms occasionally causing mild nausea, bitter taste, and transient loose stools. While its safety has not been evaluated in depth in large prospective studies in humans, dragon’s blood is generally regarded as safe, and in several small clinical trials it has not been implicated in any severe adverse events.

### Hepatotoxicity

In small clinical trials for a variety of indications, dragon’s blood has not been implicated in causing serum enzyme or bilirubin elevations during therapy. In controlled trials of crofelemer, an extract of dragon’s blood that is approved for use in non-infectious diarrhea, serum aminotransferase abnormalities arose in 1% to 2% of subjects, but the elevations were mild, transient and asymptomatic, not requiring dose modification or discontinuation. Furthermore, there have been no published reports of clinically apparent liver injury attributed to dragon’s blood or crofelemer, and multiple large registries and case series of drug and dietary supplement induced liver injury have not included dragon’s blood or crofelemer in lists of suspected causes.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Herbal and Dietary Supplements, Crofelemer

Other names: Sangre de drago, Sangre de draco, Sangre de grado, Xue Jie.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dragon’s Blood – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
SP-303; [Crofelemer] | 148465-45-6 | C18-H16-N2-O3
Taspine | 602-07-3 | C20-H19-NO6

## ANNOTATED BIBLIOGRAPHY

References updated: 03 June 2024

Abbreviations: DILI, drug-induced liver injury; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal and dietary supplements [HDS] are discussed, but not dragon’s blood).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements published in 2007; no mention of dragon’s blood).
Dragon’s Blood (Xue-Jie). In, PDR for Herbal Medications. 4th ed. Montvale, NJ. Thompson Healthcare Inc. 2007: pp. 263. (Monographs on herbal products mention that dragons’s blood is a red resin extract from Dragon trees, Daemonorops draco or propinquis, native to Malaysia and Indonesia).
Ubillas R, Jolad SD, Bruening RC, Kernan MR, King SR, Sesin DF, Barrett M, et al. SP-303, an antiviral oligomeric proanthocyanidin from the latex of Croton lechleri (Sangre de Drago). Phytomedicine. 1994;1(2):77-106. (Description of extraction of dragon’s blood rich in catechins and that has antiviral activity in cell culture). 23195881
Holodniy M, Koch J, Mistal M, Schmidt JM, Khandwala A, Pennington JE, Porter SB. A double blind, randomized, placebo-controlled phase II study to assess the safety and efficacy of orally administered SP-303 for the symptomatic treatment of diarrhea in patients with AIDS. Am J Gastroenterol. 1999;94:3267-73. (Among 51 adults with AIDS and non-infectious diarrhea treated with SP-303 [crofelemer] or placebo every 6 hours for 4 days, reduction in stool weight was greater with crofelemer [-451 vs -150 gm daily by day 4] and there were no serious adverse events or changes in laboratory values). 10566728
Carlson TJS, King SR. Sangre de Drago (Croton lechleri Muell.- Arg.)—a phytomedicine for the treatment of diarrhea. Healthnotes Rev Complement Integrative Med. 2000;7:315-320. Not in PubMed. (Review of SP-303, a purified extract of Croton lechleri consisting largely of oligomeric proanthocyanidin which inhibits cyclic AMP-mediated chloride secretion in vitro, probably via the cystic fibrosis transmembrane regulator [CFTR]; in multiple clinical trials in humans oral SP-303 was shown to be not absorbed but was effective in improving traveler’s and endemic watery diarrhea as well as HIV-associated non-infectious watery diarrhea; in all studies it was described as well tolerated with no differences in adverse events from what occurred with placebo).
DiCesare D, DuPont HL, Mathewson JJ, Ashley D, Martinez-Sandoval F, Pennington JE, Porter SB. A double blind, randomized, placebo-controlled study of SP-303 (Provir) in the symptomatic treatment of acute diarrhea among travelers to Jamaica and Mexico. Am J Gastroenterol. 2002;97:2585-8. (Among 184 adults with traveler’s diarrhea treated with SP-303 [125, 250, or 500 mg] or placebo 4 times daily for 2 days, the time to formed stool was less with the herbal product [30-32 hours] than with placebo [39 hours] and was well tolerated at all doses with no serious adverse events). 12385443
Jones K. Review of sangre de drago (Croton lechleri)--a South American tree sap in the treatment of diarrhea, inflammation, insect bites, viral infections, and wounds: traditional uses to clinical research. J Altern Complement Med. 2003;9:877-96. (Review of the source, phytochemistry, in vitro and in vivo biologic effects, clinical efficacy, and safety of dragon’s blood [sangre de drago] derived from the South America tree Croton lechleri which has bioactive alkaloids [taspine], phenolic compounds [lignans], tannins, procyanidins [catechins], diterpenes, and steroids and is used commonly in South America topically for wounds, herpes virus ulcers, and insect bites, and orally for diarrhea and several other conditions, while side effects are minimal even with oral use; no mention of hepatotoxicity). 14736360
Fischer H, Machen TE, Widdicombe JH, Carlson TJ, King SR, Chow JW, Illek B. A novel extract SB-300 from the stem bark latex of Croton lechleri inhibits CFTR-mediated chloride secretion in human colonic epithelial cells. J Ethnopharmacol. 2004;93(2-3):351-7. (An extract of the resin from the Dragon tree, Croton lechleri, that acts by decreasing inhibition of the cystic fibrosis chloride transporter decreasing chloride secretion in colonic epithelial cells in vitro which may explain its effect on diarrhea). 15234776
Gupta D, Bleakley B, Gupta RK. Dragon's blood: botany, chemistry and therapeutic uses. J Ethnopharmacol. 2008;115:361-80. (Review of the various sources and forms of dragon’s blood derived from different species of shrubs and trees, their phytochemistry and laboratory and clinical evidence of activity as analgesic, hemostatic, antidiarrheal, antirheumatic, antitumor, antiviral, wound healing, cardio-protective, neuroprotective, antiinflammatory, and antioxidant agents). 18060708
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Among 778 spontaneous reports of adverse reactions to herbal and alterative medicines to a national Swedish Registry, no cases were attributed to dragon’s blood). 19650152
Tradtrantip L, Namkung W, Verkman AS. Crofelemer, an antisecretory antidiarrheal oligomer extracted from Croton lechleri, targets two distinct intestinal chloride channels. Mol Pharmacol 2010; 77: 69-78. (Investigation of the antidiarrheal mechanism of action of crofelemer, an extract of the sap of the dragon tree Croton lechleri, found that it inhibited two different chloride channels [CFTR and calcium-activated chloride channels] in vitro in human intestinal cell lines). 19808995
Macarthur RD, Hawkins TN, Brown SJ, LaMarca A, Clay PG, Barrett AC, Bortey E, et al. Efficacy and safety of crofelemer for noninfectious diarrhea in HIV-seropositive individuals (ADVENT trial): a randomized, double-blind, placebo-controlled, two-stage study. HIV Clin Trials 2013; 14: 261-73. (Among 374 adults with HIV infection and noninfectious diarrhea attributed to antiretroviral therapy enrolled in a two-stage, placebo controlled study of different doses of crofelemer, serum levels were undetectable in 96% of patients and adverse event rates were similar to those of placebo; during open label extension study, serum ALT elevations occurred in 2.7% of crofelemer treated subjects, but all resolved and there were no serious adverse hepatic events or instances of clinically apparent liver injury). 24334179
Crofelemer (Fulyzaq) for antiretroviral-induced diarrhea. Med Lett Drugs Ther 2013; 55(1421): 59-60. (Concise review of the mechanism of action, efficacy, safety, and costs of crofelemer as therapy of noninfectious diarrhea in patients with HIV infection taking antiretroviral agents mentions that adverse events are uncommon and mild; no mention of ALT elevations or hepatotoxicity). 23863919
Frampton JE. Crofelemer: a review of its use in the management of non-infectious diarrhea in adult patients with HIV/AIDS on antiretroviral therapy. Drugs 2013; 73: 1121-9. (Systematic review of the literature on the mechanism of action, efficacy and safety of crofelemer in noninfectious diarrhea among antiretroviral treated adults with HIV infection mentions that adverse events were uncommon and mild but could include flatulence [3.1%], abdominal distention [1/7%], constipation [1.7%], dyspepsia [1.3%], nausea [1.3%] and ALT elevations [1.3%]). 23807722
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs, and supplements but does not list or mention dragon’s blood). 22928722
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies; no mention of dragon’s blood). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs and dietary supplements collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to dragon’s blood). 25043597
Namjoyan F, Kiashi F, Moosavi ZB, Saffari F, Makhmalzadeh BS. Efficacy of Dragon's blood cream on wound healing: A randomized, double-blind, placebo-controlled clinical trial. J Tradit Complement Med. 2015;6:37-40. (Randomized controlled trial of dragon’s blood cream vs placebo [applied twice daily] on healing of 100 wounds from 60 patients after removal of skin tags demonstrated faster healing with the herbal cream [78% vs 44% by 7 days] with no adverse effects reported). 26870678
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss dragon’s blood). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish Drug-Induced Liver Injury Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of dragon’s blood). 29307848
Pona A, Cline A, Kolli SS, Taylor SL, Feldman SR. Review of future insights of Dragon's Blood in dermatology. Dermatol Ther. 2019;32:e12786. (Review of the possible dermatologic uses of dragon’s blood [sangre de draco] derived from Croton lechleri, a tree found in low mountainous areas of South America, the sap of which has been used in traditional medicine freshly or as a powder for wound healing, hives, sore throat, and diarrhea, active components being proanthocyanidins, catechins, phenols, flavonoids, diterpenes, taspine, and sterols; side effects of oral therapy being mild nausea, bitter taste, and occasional diarrhea). 30556246
Al-Awthan YS, Bahattab OS. Phytochemistry and pharmacological activities of Dracaena cinnabari resin. Biomed Res Int. 2021;2021:8561696. (Review of the phytochemistry and pharmacological activities of resin from Dracaena cinnabari, a small, much branched tree found in tropical and subtropical areas, most commonly in Yemen; the resin is harvested from the sap that runs from cut stems and purportedly has antioxidant, antiinflammatory, hypoglycemic, antispasmodic, analgesic, antimicrobial, antineoplastic, cardiotonic, and neuroprotective activities although the component(s) responsible for these activities is not known). 34337055
Liu Y, Zhao X, Yao R, Li C, Zhang Z, Xu Y, Wei JH. Dragon's blood from Dracaena worldwide: species, traditional Uses, phytochemistry and pharmacology. Am J Chin Med. 2021;49:1315-1367. (Extensive review of the phytochemistry and biologic activities of dragon’s blood resin prepared from Dracaena species, the most widely used source of dragon’s blood which is frequently used in traditional Chinese medicine for wound healing, pain, inflammation, digestive disorders, ulcers and dysentery, but also as preventive therapy for cardiovascular, cerebrovascular, and neurologic diseases). 34247562
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90], Herbalife products [64], kava kava [62], and greater celandine [48]; dragon’s blood is not listed or discussed). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; dragon’s blood is not mentioned). 33434654

## OTHER REFERENCE LINKS

Recent References on Dragon’s Blood: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dragon%E2%80%99s+Blood+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Dragon’s Blood: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dragon%E2%80%99s%20Blood)